# Mefenamic Acid

## OVERVIEW

### Introduction

Mefenamic acid is a nonsteroidal anti-inflammatory drug (NSAID) used largely for acute treatment of pain. Mefenamic acid has been linked to rare instances of clinically apparent, acute liver injury.

### Background

Mefenamic (mef" e nam' ik) acid belongs to the anthranilic acid derivative class of NSAIDs (fenamates). Like other NSAIDs, mefenamic acid is a cyclo-oxygenase (Cox-1 and -2) inhibitor and blocks the production of intracellular proinflammatory prostaglandins that are important in pain and inflammatory pathways. Mefenamic acid has analgesic as well as antipyretic and anti-inflammatory activities, but is used largely for treatment of pain. Mefenamic acid was approved in the United States in 1967, but is not a commonly used agent. Mefenamic acid is indicated for the treatment of mild-to-moderate acute pain or dysmenorrhea. It is available by prescription only in capsules of 250 and 500 mg in generic forms and under the brand name Ponstel. The recommended dose is 250 to 500 mg 3 to 4 times daily for periods of less than 7 days. Like most NSAIDs, mefenamic acid is generally well tolerated, but side effects can include headache, dizziness, somnolence, nausea, diarrhea, abdominal discomfort, heartburn, peripheral edema and hypersensitivity reactions. Rare but serious adverse events from NSAIDs include gastrointestinal ulceration and bleeding, increased risk for cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, edema, and hypersensitivity reactions including anaphylaxis, exfoliative dermatitis and Stevens Johnson syndrome.

### Hepatotoxicity

In prospective studies less than 5% of patients taking mefenamic acid experienced transient serum aminotransferase elevations. The abnormalities usually resolved even while continuing the drug and without dose modification. Marked aminotransferase elevations (>3 fold elevated) occurred in <1% of patients. There have been isolated, rare cases of mefenamic acid induced liver injury published, but mefenamic acid is not mentioned as an etiologic agent in large case series on drug induced liver injury or acute liver failure. In some published cases, the liver injury arose as a part of a severe hypersensitivity reaction to mefenamic acid, such as Stevens Johnson syndrome or anaphylaxis. The latency to onset was short (less than one month and often within a few days) and the pattern injury variable from cholestatic to hepatocellular. The paucity of cases makes it difficult to characterize a typical clinical pattern of injury. Only a few rare instances of clinically apparent liver injury due to mefenamic acid have been reported.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of mefenamic acid hepatotoxicity is not known, but is likely to be idiosyncratic hypersensitivity. The absence of reports of liver injury from mefenamic acid may be due, in part, to the infrequency of its use and limited duration of treatment (for seven days or less).

### Outcome and Management

The asymptomatic elevations in serum aminotransferase levels during mefenamic acid therapy are usually self-limited and resolve even with continuing mefenamic acid. Severe cases of mefenamic acid hepatotoxicity, but not fatal cases or cases leading to chronic liver injury, have been described. Cross reactivity to hepatic injury among various classes of NSAIDs has not been well characterized; however, after clinically apparent injury attributable to mefenamic acid, it would be prudent to avoid other anthranilic acid derivatives (fenamates generally not available in the United States, such as tolfenamic acid and flufenamic acid), and patients who are switched to other NSAIDs should be monitored carefully.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mefenamic Acid – Ponstel®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=mefenamic+acid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mefenamic Acid | 61-68-7 | C15-H15-N-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2025

Abbreviations used: NSAID, nonsteroidal anti-inflammatory drug; COX-1 and -2, cyclo-oxygenase 1 and 2; DRESS, drug reaction with eosinophilia and systemic symptoms; VBDS, vanishing bile duct syndrome.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999: mentions that minor aminotransferase elevations occur in less than 5% of mefenamic acid recipients and was incriminated in an instance of “severe, but nonfatal, bridging necrosis”: Imoto).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs mentions that mefenamic acid has been associated with only one published case of severe, but non-fatal hepatic necrosis: Imoto).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709.
(Textbook of pharmacology and therapeutics) .
Imoto S, Matsumoto H, Fujii M. Drug-related hepatitis. Ann Intern Med 1979; 91: 129. (Letter to editor stating that 35 patients with drug induced liver disease were seen over 6 years at a single Japanese center; 9 had severe bridging necrosis on liver biopsy; one case being attributed to mefenamic acid; but no details given of latency, test results, clinical features, course or competing diagnoses). 464433
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive and excellent review article on liver injury due to NSAIDs; mefenamic acid is mentioned as being associated with a single case report of hepatocellular injury [Imoto]). 2281340
Chan JCN, Lai FM, Critchley JAJH. A case of Stevens-Johnson syndrome, cholestatic hepatitis and hemolytic anemia associated with use of mefenamic acid. Drug Saf 1991; 6: 230-4. (44 year old woman developed rash after 2 weeks of mefenamic acid [with acetaminophen and furosemide] presenting with Stevens-Johnson syndrome, hemolytic anemia and bilirubin 18.0 mg/dL, ALT 427 U/L, Alk P 1220 U/L and renal failure progressing to multiorgan failure and death in 4 days, autopsy showed intrahepatic cholestasis and acute tubular necrosis). 2064763
Schwartz D, Gremmel F, Kurz R, Tragl KH, Gellner B, Pausch V. Case report: acute renal failure, thrombocytopenia and nonhemolytic icterus probably caused by mefenamic acid(Parkemed)-dependent antibodies. Beitr Infusionsther 1992; 30: 413-5. (65 year old man developed acute renal failure and thrombocytopenia shortly after a 3 day course of mefenamic acid followed by jaundice [bilirubin 20.7 mg/dL] which was attributed to "an isolated defect in glucuronidation"; patient recovered and no other details given). 1284748
de Mello NR, Baracat EC, Tomaz G, Bedone AJ, Camargos A, Barbosa IC, de Souza RN, et al. Double-blind study to evaluate efficacy and safety of meloxicam 7.5 mg and 15 mg versus mefenamic acid 1500 mg in the treatment of primary dysmenorrhea. Acta Obstet Gynecol Scand 2004; 83: 667-73. (Controlled trial of 2 doses of meloxicam vs mefenamic acid for 3 to 5 days in 337 women with dysmenorrhea, aminotransferase elevations occurred in 2 of 227 meloxicam-, but in none of 110 mefenamic acid treated subjects). 15225193
Somchit N, Sanat F, Gan EH, Shahrin IA, Zuraini A. Liver injury induced by the non-steroidal anti-inflammatory drug mefenamic acid. Singapore Med J 2004; 45: 530-2. (Study in mice: dose dependent hepatotoxicity found with single intraperitoneally injection of 100-200 mg/kg as well as 14 day course at 50-100 mg/kg of mefenamic acid). 15510325
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. (Review of randomized clinical trial of NSAIDS for frequency of adverse events; ALT >3 fold ULN in 0.43% of ibuprofen, 0.43% naproxen, 0.42% celecoxib, 1.8% rofecoxib, 3.55% diclofenac and 0.29% of placebo recipients, rare liver related severe adverse events or deaths with any; no mention of mefenamic acid). 15880319
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: among 103 cases, 3 attributed to naproxen, but none to mefenamic acid). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20:391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; mefenamic acid was not listed among more than 29,000 liver adverse event reports). 16867024
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; none for mefenamic acid). 18955056
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; no mention of mefenamic acid). 21128314
Couto M, Duarte C, Geraldes L, Inês L, Malcata A. Anaphylaxis to mefenamic acid in a patient with new onset of systemic lupus erythematosus. Allergol Immunopathol (Madr) 2010; 38: 224-6. (32 year old woman with lupus developed rash, followed by angioedema and anaphylactic shock a week after starting mefenamic acid for suspected lupus with accompanying hemolytic anemia, thrombocytopenia and liver test abnormalities [bilirubin 0.8 mg/dL, ALT 219 U/L, prothrombin time 22 sec], which rapidly improved with medical support and high dose corticosteroid therapy). 20153574
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 to bromfenac, 2 to diclofenac and 1 to etodolac, but none to mefenamic acid). 20949552
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09] piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]; mefenamic acid not discussed). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none for mefenamic acid or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996-2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; mefenamic acid was not listed]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, but none to mefenamic acid [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled between 2004 and 2014 into a prospective, US database, 30 cases [2.5%] were attributed to NSAIDs, including 16 to diclofenac, 3 celecoxib, 3 meloxicam, 2 etodolac, 2 oxaprozin, 2 ibuprofen, 1 sulindac, and 1 valdecoxib, but none to mefenamic acid). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59], and risk was higher in those taking higher doses; mefenamic acid is not listed). 26991794
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of Nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol 2018; 2018: 5253623. (Systematic review of published randomized controlled trials for evidence of hepatotoxicity, found 18 studies that fit the stringent criteria, but none of them dealt with mefenamic acid). 29568654
Ben-Nasr H, Ksouda K, Harrabi B, Hammami ST, Zeghal K, Affes H. Pediatric liver failure following mefenamic acid associated to herbal auto-medication: A case report. Therapie 2019; 74: 677-80. (4 year old boy developed severe acute hepatocellular liver injury [ALT 1920 U/L, GGT 283 U/L, bilirubin 6.4 mg/dL, INR 1.52] 2 weeks after starting a mefenamic acid based cough medication and while intermittently receiving a home brewed herbal tea prepared from nutmeg [Mirystica fragrans], a flower [Hibiscus saabdariffa] and mint [Mentha aquatic], recovering within 3 weeks of presentation). 31635831
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen, and aspirin and that rare instances of idiosyncratic acute hepatitis attributed to celecoxib have been described; mefenamic acid not discussed). 29469052
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623.. (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib). 29568654
Ben-Nasr H, Ksouda K, Harrabi B, Hammami ST, Zeghal K, Affes H. Pediatric liver failure following mefenamic acid associated to herbal auto-medication: a case report. Therapie. 2019;74:677-680.. (4 year old child on 3 herbal medications developed acute liver injury 4 days after starting mefenamic acid [bilirubin 6.4 mg/dL, ALT 1960 U/L, Alk P 537 U/L, INR 1.5] recovering with conservative management after stopping all medications). 31635831
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to mefenamic acid). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; mefenamic acid was not mentioned). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases due to diclofenac for an estimated incidence of 1 per 4,800 new persons treated each year, while other NSAIDs had lower numbers and estimated rates, including celecoxib [4, 1:25,000] and meloxicam [n=3, 1:87,000], there were no cases due to mefenamic acid, and its incidence could not be estimated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam; but none to mefenamic acid [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Mefenamic Acid: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(mefenamic+acid/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Mefenamic Acid: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=mefenamic)